# Teplizumab

## OVERVIEW

### Introduction

Teplizumab is a humanized monoclonal antibody to CD3 which is used to delay the onset of clinically significant type 1 diabetes (stage 3 diabetes) in a patient at high risk as shown by the presence of anti-pancreatic islet cell autoantibodies and dysglycemia (stage2 diabetes). Teplizumab is given intravenously once daily for 14 days, is generally well tolerated, and is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Teplizumab (tep liz’ ue mab) is a humanized monoclonal IgG1 antibody directed against CD3, which results in inhibition of cytotoxic T cell activation and proliferation. Because type 1 diabetes is thought to be caused by cytotoxic T cell destruction of pancreatic islet beta cells that produce insulin, teplizumab was evaluated as a means of therapy and prevention of type 1 diabetes. While a limited course of teplizumab appeared to have little effect on established type 1 diabetes, it did appear to delay the onset of clinically apparent type 1 diabetes. In preregistration trials, stage 2 diabetes was defined by the presence of at least two anti-pancreatic islet cell autoantibodies and dysglycemia without frank hyperglycemia (stage 3 diabetes). Patients with stage 2 diabetes were generally identified among relatives of patients with type 1 diabetes by screening for anti-pancreatic islet cell autoantibodies. Natural history studies demonstrated that almost all subjects with stage 2 diabetes develop stage 3 diabetes, generally within 1 to 5 years. In a single, randomized controlled trial of teplizumab given as daily intravenous infusions daily for 14 days, therapy was associated with a subsequent median delay in onset of stage 3 diabetes of 24 months. On the basis of this trial, teplizumab was approved in 2022 the United States for use in preventing stage 3 diabetes in adults and children (8 years of age or older) with stage 2 diabetes. Teplizumab is available in single use vials of 2 mg per 2 mL (1 mg/mL). The recommended regimen is a daily infusion in escalating doses for the first 5 days from 65 to 1,030 µg/m^2^, which is then continued for another 9 days. Premedication is recommended at least during the first 5 days using an oral analgesic (acetaminophen or a nonsteroid antiinflammatory agent), antihistamine, and antiemetic. Monitoring of symptoms, blood counts and liver enzymes is also recommended during the 14 days. Common side effects during and for the several weeks after treatment include mild local injection reactions, nasopharyngitis, fatigue, headache, nausea, diarrhea, arthralgia and skin rash. Uncommon, potentially severe adverse reactions include cytokine release syndrome, severe hypersensitivity reactions, lymphopenia, and reactivation of latent viral infections or tuberculosis.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise in up to 25% of patients treated with teplizumab, usually during the 14 days of therapy and often associated with evidence of mild-to-moderate cytokine release syndrome. The ALT and AST elevations are usually mild, transient and asymptomatic, rising to above 3 times the upper limit of normal (ULN) in 5% of patients and rarely necessitating drug discontinuation. Serum bilirubin levels also rise, particularly in patients with cytokine release syndrome, but clinically apparent liver injury with jaundice has not been reported, and liver test abnormalities resolve in almost all patients within days or a few weeks of ending the 14 day course. There has been limited clinical experience with use of teplizumab and scant information on the safety and efficacy of repeated courses of treatment. Development of antibodies to teplizumab is not uncommon (up to 50%), but the clinical significance of drug antibodies has not been defined.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to teplizumab are unclear, but probably relate to cytokine release induced by the binding of the monoclonal antibody to activated T cells that then release cytokines into the circulation that can cause transient liver injury. There is no evidence that the cytokine release induced by teplizumab can result in prolonged or chronic liver injury.

### Outcome and Management

Drug Class: Monoclonal Antibodies, Antidiabetic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Teplizumab – Tzield®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teplizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Teplizumab | 876387-05-2 (https://pubchem.ncbi.nlm.nih.gov/substance/135310211) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2023

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/761183Orig1s000MedR.pdf (Multidisciplinary FDA review of teplizumab in support of its approval for use to delay the onset of type 1 diabetes in high risk children and adults mentions that ALT or AST elevations and total bilirubin levels often rise during the 14 day course of teplizumab therapy and ALT elevations occur in 25% of subjects, but are above 3 times ULN in only 5%).
Sherry N, Hagopian W, Ludvigsson J, Jain SM, Wahlen J, Ferry RJ, Bode B, et al., Protégé Trial Investigators. (2011). Teplizumab for treatment of type 1 diabetes (Protégé study): 1-year results from a randomised, placebo-controlled trial. Lancet. (Among 516 patients, ages 8 to 35 years, with newly diagnosed type 1 diabetes treated with 1 of 3 dose regimens of teplizumab [14 days or 6 days of full dose, 14 days of half dose] or placebo at baseline and 26 weeks, there were no differences in response rates, total and severe adverse event rates but higher rates of some adverse events including rash [52% to 54% vs 20%] lymphopenia [69% to 75% vs 19%], fatigue [9% to 14% vs 5%], cytokine release syndrome [2-8% vs 0], and ALT elevations [25% to 34% vs 16%]).
Hagopian W, Ferry RJ, Sherry N, Carlin D, Bonvini E, Johnson S, Stein KE, Koenig S, et al., Protégé Trial Investigators. (2013). Teplizumab preserves C-peptide in recent-onset type 1 diabetes: two-year results from the randomized, placebo-controlled Protégé trial. Diabetes. (Further analysis of the Protégé Trial [Sherry 2011] at two years found that teplizumab therapy of newly diagnosed diabetes resulted in relative preservation of C peptide levels, while new adverse events include herpes zoster, which arose in 10 patients who received teplizumab vs none on placebo, some cases occurring long after the infusions; no differences in rates of herpes simplex, EBV or CMV infections in treatment vs placebo groups, and no mention of hepatitis B).
Herold KC, Bundy BN, Long SA, Bluestone JA, DiMeglio LA, Dufort MJ, Gitelman SE, et al. (2019). Type 1 Diabetes TrialNet Study Group. An anti-CD3 antibody, teplizumab, in relatives at risk for type 1 diabetes. N Engl J Med. (Among 76 subjects with stage 2 diabetes [ages 8.5 to 49.5 years] treated with a single 14 day course of teplizumab or placebo, subsequent diagnosis of diabetes 43% in teplizumab vs 72% in placebo recipients, while adverse events more frequent with active drug included rash [36% vs 3%] and EBV reactivation [18% vs 0], while rates of infection and “hepatobiliary” events were similar in the two groups).
Perdigoto AL, Preston-Hurlburt P, Clark P, Long SA, Linsley PS, Harris KM, Gitelman SE, et al., Immune Tolerance Network. (2019). Treatment of type 1 diabetes with teplizumab: clinical and immunological follow-up after 7 years from diagnosis. Diabetologia. (Long term follow up [median 7.3 years] of 43 patients with type 1 diabetes who were treated with teplizumab found sustained preservation of C-peptide levels in comparison to placebo recipients in some patients, but no differences in hemoglobin A1c levels or insulin requirements; no mention of ALT elevations or hepatotoxicity).
(2023). Teplizumab (Tzield) to delay onset of type 1 diabetes. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, adverse effects, and costs of teplizumab shortly after its approval for use in prevention of type 1 diabetes, mentions that its adverse events include cytokine release symptom [fever, nausea, fatigue, headache, myalgia, arthralgia and increase liver enzyme and bilirubin levels] that occurs in 5% of patients, usually within the first 5 days of therapy).

## OTHER REFERENCE LINKS

1 Recent References on Teplizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Teplizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Teplizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teplizumab)